# Mitotane

## OVERVIEW

### Introduction

Mitotane is a unique antineoplastic agent used solely in the therapy of metastatic, unresectable adrenocortical carcinoma. Mitotane has been associated with a high rate of serum enzyme elevation during therapy, but has had limited clinical use and has not been linked to instances of clinically apparent acute liver injury.

### Background

Mitotane (mye' toe tane) is an isomer of DDT (dichloro-diphenyl-trichloroethane) which was found to cause adrenal atrophy in dogs and was later developed as an antineoplastic agent for advanced or metastatic adrenocortical carcinoma. Mitotane is directly cytotoxic to adrenal tissue and appears to act by inhibition of sterol-O-acyl-transferase (SOAT) activity which blocks the esterification of cholesterol. Cholesterol is the precursor of adrenocortical hormones and it accumulates in adrenocortical cells. The prevention of esterification causes an excess of free cholesterol and other fatty acids which are is toxic to the hormone producing adrenal cells. Treatment with mitotane regularly causes a decrease in corticosteroid synthesis and can result in adrenal insufficiency and Addisonian crisis. Mitotane was approved for use in the chemotherapy of advanced adrenal carcinoma in the United States in 1970. It is available as tablets of 500 mg under the brand name Lysodren. The typical initial dose is 2 to 6 grams daily in 3 to 4 divided doses, which can be increased to achieve a blood concentration of 14 to 20 mg/L. Side effects of mitotane therapy are common and can include anorexia, nausea, vomiting, diarrhea, depression, dizziness, decreased memory and concentration, rash, gynecomastia, arthralgia and leukopenia. Potentially severe adverse events include adrenal insufficiency and crisis.

### Hepatotoxicity

Serum aminotransferase elevations occur in up to half of patients on conventional doses of mitotane therapy, but elevations above 5 times the upper limit of normal are uncommon (<1%). There have been no individual published case reports of clinically apparent liver injury attributed to mitotane, but its general use has been limited, as adrenocortical carcinoma is rare. Furthermore, the nonspecific side effects of mitotane therapy are often dose limiting and may be mediated, at least in part, by hepatic dysfunction or injury perhaps due to the same lipotoxicity that accounts for adrenocortical injury.

Likelihood score: E* (unproven but suspected rare cause of clinically apparent liver injury).

### Mechanism of Injury

While hepatotoxicity from mitotane may be rare, it is likely due to direct hepatotoxicity. Mitotane is extensively metabolized in the liver via the microsomal enzyme system (predominantly 2C9), and production of a toxic or immunogenic intermediate may trigger liver injury.

### Outcome and Management

The severity of the liver injury linked to mitotane therapy has been generally mild, transient and without symptoms or jaundice. Mitotane has not been linked to cases of acute liver failure, chronic hepatitis or vanishing bile duct syndrome. There is no information on cross sensitivity to hepatic injury between mitotane and other antineoplastic agents.

Drug Class: Antineoplastic Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Mitotane – Lysodren®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Mitotane)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Mitotane | 53-19-0 | C14-H10-Cl4
DDT | 50-29-3 | C14-H9-Cl5

## ANNOTATED BIBLIOGRAPHY

References updated: 19 February 2020

Zimmerman HJ. Hepatotoxic effects of oncotherapeutic and immunosuppressive agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 673-708. (Expert review of hepatotoxicity of cancer chemotherapeutic agents published in 1999; mentions that mitotane can cause elevations in serum aminotransferase levels).
DeLeve LD. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam, Elsevier, 2013, p. 541-68. (Review of hepatotoxicity of cancer chemotherapeutic agents; mitotane is not discussed).
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Cytotoxic agents. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1167-203. (Textbook of pharmacology and therapeutics).
Montgomery DA, Welbourn RB. (1965). Adrenocortical carcinoma treated with O,P' -DD. Br Med J. (3 year old girl presented with Cushing syndrome and was found to have a large adrenocortical carcinoma, which was resected but recurred with metastases to the liver and lung that responded transiently to mitotane therapy, but ultimately led to her death; mentions that blood counts and liver tests did not change during therapy).
Hutter AM, Kayhoe DE. (1966). Adrenal cortical carcinoma. Results of treatment with o,p'DDD in 138 patients. Am J Med. (Among 138 patients with adrenocortical carcinoma treated with mitotane, toxicities were largely dose related and included gastrointestinal [anorexia, nausea, vomiting, diarrhea] and CNS effects [lethargy, somnolence, neuromotor disturbances], while "the absence of bone marrow and liver toxicity deserves emphasis").
Hoffman DL, Mattox VR. (1972). Treatment of adrenocortical carcinoma with o,p'-DDD. Med Clin North Am. (Among 19 patients with adrenocortical carcinoma treated with mitotane [o,p-DDD] between 1959 and 1971, most showed evidence of suppression of corticosteroid production and objective tumor regression occurred in 4, but mitotane was poorly tolerated and was suspected to be causing liver injury in one patient, but a liver biopsy was said to be normal).
Hajjar RA, Hickey RC, Samaan NA. (1975). Adrenal cortical carcinoma. A study of 32 patients. Cancer. (Review of 32 cases of adrenocortical carcinoma seen at MD Anderson Hospital between 1950 and 1972, 15 of whom received mitotane, most of whom had little response to treatment although side effects were frequent; no mention of ALT elevations and hepatotoxicity).
Hogan TF, Citrin DL, Johnson BM, Nakamura S, Davis TE, Borden EC. (1978). o,p'-DDD (mitotane) therapy of adrenal cortical carcinoma: observations on drug dosage, toxicity, and steroid replacement. Cancer. (Among 4 patients with adrenocortical carcinoma treated with mitotane, all had severe toxicity including adrenal insufficiency).
Gutierrez ML, Crooke ST. (1980). Mitotane (o,p'-DDD). Cancer Treat Rev. (Review of the development of mitotane, an isomer of DDT (o,p-DDD) which was found to cause severe adrenal cortical atrophy in dogs, and was later developed as a therapy of human adrenocortical carcinoma where clinical responses were found in 35-54% of patients and toxicities included gastrointestinal [79%] and CNS toxicity [49%], and more rarely skin rash, eye, genitourinary and cardiovascular injury; no mention of ALT elevations or hepatotoxicity).
Luton JP, Cerdas S, Billaud L, Thomas G, Guilhaume B, Bertagna X, Laudat MH, et al. (1990). Clinical features of adrenocortical carcinoma, prognostic factors, and the effect of mitotane therapy. N Engl J Med. (Review of the clinical features and courses of 105 patients with adrenocortical carcinoma seen between 1963 and 1987 of whom 59 received mitotane which controlled hormone levels in 75% of patients, although survival did not seem to be improved; side effects were common and largely gastrointestinal [anorexia, nausea] or neurologic [ataxia, somnolence] and "most patients had hepatic disturbances" including increases in ALT, AST, GT and Alk P, but no mention of jaundice or clinically apparent liver injury).
Haak HR, Hermans J, van de Velde CJ, Lentjes EG, Goslings BM, Fleuren GJ, Krans HM. (1994). Optimal treatment of adrenocortical carcinoma with mitotane: results in a consecutive series of 96 patients. Br J Cancer. (Among 96 patients with adrenocortical carcinoma with mitotane between 1959 and 1992, patient responses and improved survival was found in those who achieved high levels of mitotane [≥14 g/L] and side effects were mainly anorexia, nausea, diarrhea and [with high doses] CNS toxicity; no mention of ALT elevations or hepatotoxicity).
Webb CB, Twedt DC. (2006). Acute hepatopathy associated with mitotane administration in a dog. J Am Anim Hosp Assoc. (8 year old mixed breed bitch developed jaundice one month after starting and 2 weeks after stopping mitotane for suspected hyperadrenocorticism [bilirubin 9.1 mg/dL, ALT 1091 U/L, Alk P 2371 U/L, GGT 37 U/L], liver biopsy showing parenchymal collapse and vacuolated hepatocytes, recovering after treatment with ursodiol, vitamin E and S-adenosylmethionine).
Terzolo M, Angeli A, Fassnacht M, Daffara F, Tauchmanova L, Conton PA, Rossetto R, et al. (2007). Adjuvant mitotane treatment for adrenocortical carcinoma. N Engl J Med. (Among 177 patients with adrenocortical carcinoma undergoing surgical resection, the 47 who received adjuvant mitotane had a prolonged overall and recurrence free survival; side effects included ALT or AST elevations in 49%, but all were transient or symptomatic and none were above 5 times ULN).
Wängberg B, Khorram-Manesh A, Jansson S, Nilsson B, Nilsson O, Jakobsson CE, Lindstedt S, et al. (2010). The long-term survival in adrenocortical carcinoma with active surgical management and use of monitored mitotane. Endocr Relat Cancer. (Among 43 patients with adrenocortical carcinoma treated with surgery and monitored mitotane, survival was improved in those with drug levels above 14 mg/L, but only 24 patients [56%] could tolerate and achieve these levels; no mention of ALT elevations or hepatotoxicity).
Fassnacht M, Terzolo M, Allolio B, Baudin E, Haak H, Berruti A, Welin S, et al., FIRM-ACT Study Group. (2012). Combination chemotherapy in advanced adrenocortical carcinoma. N Engl J Med. (Among 304 patients with adrenocortical carcinoma treated with mitotane and either etoposide with doxorubicin and cisplatin [mit-EDC] or streptozocin [mit-S], objective responses were more frequent with mit-EDC, but overall survival was not different, and rates and patterns of side effects were similar between the two groups).
Kerkhofs TM, Baudin E, Terzolo M, Allolio B, Chadarevian R, Mueller HH, Skogseid B, et al. (2013). Comparison of two mitotane starting dose regimens in patients with advanced adrenocortical carcinoma. J Clin Endocrinol Metab. (Among 40 patients with adrenocortical carcinoma treated with 2 doses of mitotane, adverse event rates were similar and included elevations in GGT [peak 123 to 311 U/L] and, to a lesser extent, increases in ALT and AST, although no patient developed clinically apparent liver injury).
Lerario AM, Worden FP, Ramm CA, Hesseltine EA, Stadler WM, Else T, Shah MH, et al. (2014). The combination of insulin-like growth factor receptor 1 (IGF1R) antibody cixutumumab and mitotane as a first-line therapy for patients with recurrent/metastatic adrenocortical carcinoma: a multi-institutional NCI-sponsored trial. Horm Cancer. (Among 20 patients treated with mitotane, a clinical response occurred in 40%, but side effects were frequent and progression free survival only 8 weeks; one patient had persistent ALT elevations above 5 times ULN and one died of multiorgan failure).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America: an analysis of published reports. Ann Hepatol. (Among 176 reports of drug induced liver injury from Latin America published between 1996 and 2012, ten were attributed to antineoplastic agents, but none to mitotane).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 45 were attributed to antineoplastic agents, but none to mitotane).
Molitch ME. (2015). Current approaches to the pharmacological management of Cushing's disease. Mol Cell Endocrinol. (Review of the medical therapy of Cushing disease mentions that mitotane is an adrenolytic agent used to treat adrenal carcinoma but is rarely used for benign disease and that “abnormal liver function tests” are common adverse events).
Sbiera S, Leich E, Liebisch G, Sbiera I, Schirbel A, Wiemer L, Matysik S, et al. (2015). Mitotane inhibits sterol-O-acyl transferase 1 triggering lipid-mediated endoplasmic reticulum stress and apoptosis in adrenocortical carcinoma cells. Endocrinology. (Treatment of an adrenocortical cell line with mitotane showed a marked alteration of lipid-related genes and ER stress that appeared to be due to inhibition of cholesterol esterification by sterol-O-acyl transferase and accumulation of toxic levels of free cholesterol, oxysterols and free fatty acids).
Lalli E. (2015). Mitotane revisited: a new target for an old drug. Endocrinology. (Commentary of the findings of Sbiera [2015] and the proposed mechanism of action of mitotane in causing apoptosis of adrenocortical cells).
Maiter D, Bex M, Vroonen L. (2016). T'Sjoen G, Gil T, Banh C, Chadarevian R. Efficacy and safety of mitotane in the treatment of adrenocortical carcinoma: A retrospective study in 34 Belgian patients. Ann Endocrinol (Paris). (Among 34 patients with adrenocortical carcinoma treated with mitotane, adverse events were common but "never serious"; no mention of ALT elevations or hepatotoxicity).
Gupta N, Rivera M, Novotny P, Rodriguez V, Bancos I, Lteif A. (2018). Adrenocortical carcinoma in children: a clinicopathological analysis of 41 patients at the Mayo Clinic from 1950 to 2017. Horm Res Paediatr. (Among 41 children with adrenocortical carcinoma followed at the Mayo Clinic between 1950 and 2017, 20 received chemotherapy with mitotane, 8 of whom received it as monotherapy after surgical resection; no mention of ALT elevations or hepatotoxicity).

## OTHER REFERENCE LINKS

1 Recent References on Mitotane: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Mitotane+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Mitotane: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Mitotane)